# Mesalamine

## OVERVIEW

### Introduction

Mesalamine, also known as mesalazine and 5-aminosalicylate, is an orally available, antiinflammatory agent used for the treatment of ulcerative colitis to both induce and maintain remissions in disease. Mesalamine therapy has been associated with a low rate of serum enzyme elevations during therapy and with rare instances of clinically apparent acute liver injury.

### Background

Mesalamine (me sal’ a meen) is used to treat disease flares in ulcerative colitis and to maintain disease remission. Mesalamine has antiinflammatory, antioxidant and antimicrobial activity and is locally active in the large intestine in reducing inflammation and injury. Mesalamine appears to act by inhibition of lipooxygenase activity, thereby inhibiting production of leukotrienes and leading to reduction in interleukin 1 (IL-1) and tumor necrosis factor (TNF) alpha. Mesalamine was approved for use in the United States in 1985 and remains a first line agent in the therapy of ulcerative colitis, both for induction and maintenance of clinical remission. It is poorly effective in Crohn disease, its major activity being in the large, rather than the small intestine. Mesalamine by itself is largely absorbed in the small intestine and little reaches the colon. For this reason, it is formulated to avoid absorption in the upper intestine and to be released in active form in the colon. The delayed absorption is accomplished either by enteric coating or by formulation as a pro-drug that is activated in the large intestine by local conditions or bacterial enzymes. Formulations of mesalamine include extended or delayed release formulations (Pentasa, Asacol, Lialda, Apriso) and mesalamine pro-drugs including sulfasalazine, olsalazine and balsalazide. Typical doses range considerable and vary by preparation, but are generally in the range of 1.5 to 4.8 g of mesalamine daily. Mesalamine is also available as an enema (Rowasa and others) and rectal suppositories (Canasa), which are useful for ulcerative proctitis and in ameliorating symptoms in mildly active, distal ulcerative colitis.

Balsalazide (bal sal’ a zide) is a pro-drug of mesalamine that consists of 5-aminosalicylate with an azo bond to a phenyl-hydroxybenzoid acid moiety which is cleaved off in the large intestine by bacterial enzymes, releasing free mesalamine. Balsalazide was approved as treatment of mildly to moderately active ulcerative colitis in adults in the United States in 2000 and is available generically and under the brand name Colazal in capsules of 750 mg; the usual dosage being 2.25 to 6.75 g daily in three divided doses.

Olsalazine (ol sal’ a zeen) is a prodrug of mesalamine that consists of two molecules of 5-aminocsalicylate (5’5’-azodisalicylate) joined at the amino-terminus with an azo bond that is cleaved by bacterial action in the colon, releasing two molecules of mesalamine. Olsalazine was approved in the United States for maintenace of remission of ulcerative colitis in patients intolerant of sulfasalazine in 2007 and is available under the brand name Dipentum in capsules of 250 mg, the usual dose being 500 mg twice daily.

Sulfasalazine (sul" fa sal' a zeen) is a prodrug of mesalamine that consists of 5-aminosalicylate joined with an azo bond to sulfapyridine. Sulfasalazine has been used extensively in the treatment of ulcerative colitis, but adverse reactions to the sulfonamide component of the agent can be problematic and has led to a decline in its use in favor of mesalamine by itself. Because the adverse effects and hepatotoxicity of sulfasalazine is largely due to the sulfonamide component, it is discussed separately in LiverTox.

Mesalamine is generally well tolerated and adverse event rates are similar to what is reported with placebo therapy of ulcerative colitis. Side effects may include diarrhea, headache, dizziness and nausea. Hypersensitivity reactions and pancreatitis can occur, but are rare.

### Hepatotoxicity

In large registration trials of various forms of mesalamine, serum enzyme elevations were no more common with the products than with placebo therapy and were less common than with sulfasalazine. In these large studies, there were no reported instances of clinically apparent liver injury. Since approval and wide scale usage, however, there have been isolated reports of acute and chronic liver injury with jaundice attributed to mesalamine therapy. Clinically apparent liver injury is estimated to occur at an incidence of 3.2 cases per million prescriptions. Several patterns of injury have been reported, including asymptomatic and mild elevations in serum ALT levels, mild hepatitis accompanying a hypersensitivity reaction within a few days or weeks of starting (sometimes following a similar reaction to sulfasalazine), drug fever with accompanying serum enzyme elevations or mild hepatitis, and more typically, idiosyncratic cholestatic or hepatocellular liver injury (Cases 1 and 2), which typically arises after 1 to 6 months of treatment and is not accompanied by signs of hypersensitivity (rash, fever, eosinophilia). Most cases of liver injury with jaundice have been mild-to-moderate in severity and resolve rapidly upon stopping. In cases with hypersensitivity reactions, corticosteroid therapy is often used and appears to speed recovery. There have been no convincing reports of fatal acute liver injury, chronic hepatitis or vanishing bile duct syndrome attributable to mesalamine.

While fewer cases of hepatotoxicity have been reported with balsalazide and olsalazide than mesalamine, reports of enzyme elevations, jaundice, hepatitis and hepatic failure and death have been reported to the sponsor for these prodrugs. For this reason, the likelihood score for hepatotoxicity of all three agents are estimated to be the same. The hepatotoxicity of sulfasalazine is much more frequent than with mesalamine and is discussed separately.

Likelihood score (Mesalamine, Balsalazide and Olsalazine): C (probable cause of clinically apparent liver injury).

Likelihood score (Sulfasalazine): A (well documented cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of mesalamine hepatotoxicity is not well known, but may be immunologic, particularly those cases associated with immunoallergic features or drug fever. Mesalamine is formulated to avoid absorption in the upper intestine and only 10% to 20% of the dose is systematically absorbed. Mesalamine is metabolized by the liver to an acetylated molecule that is excreted in the urine. Interestingly, some cases of hypersensitivity reactions have been reported after administration of mesalamine rectally or by edema.

### Outcome and Management

Most cases of liver injury attributed to mesalamine have been mild-to-moderate in severity and rapidly reversed when the drug is stopped. There have been published instances of severe hypersensitivity reactions to mesalamine, but no typical instances of acute liver failure or vanishing bile duct syndrome. Rechallenge leads to recurrence and should be avoided. There is occasional cross sensitivity to reactions to sulfasalazine; some degree of cross sensitivity should be expected between the delayed and extended formulations and the various other pro-drugs of mesalamine (balsalazide and olsalazine).

While sulfasalazine contains mesalamine, its hepatotoxicity generally resembles that of the sulfonamides and it is dicussed and its references are given separately in LiverTox.

Drug Class: Gastrointestinal Agents, Inflammatory Bowel Disease Agents; See also Sulfasalazine

## CASE REPORTS

### Case 1. Acute cholestatic hepatitis attributed to mesalamine therapy.

[Modified from: Stoschus B, Meybehm M, Spengler U, Scheurlen C, Sauerbruch T. Cholestasis associated with mesalazine therapy in a patient with Crohn's disease. J Hepatol 1997; 26: 425-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9059966)]

A 30 year old man with Crohn disease of the ileum was treated with oral mesalazine (the term used for mesalamine in Europe) and developed nausea, fatigue, weight loss, right upper quadrant pain and jaundice four months later. He had no history of liver disease and was known to have normal routine liver tests before starting mesalamine (Table). He denied alcohol use and was evidently not taking other medications. On examination, he was jaundiced and had right upper quadrant tenderness, but no evidence of chronic liver disease and no fever or rash. Laboratory testing showed serum bilirubin of 6.0 mg/dL, ALT 393 U/L, GGT 166 U/L and alkaline phosphatase 201 U/L. The total white blood cell count was normal as was the absolute eosinophil count (294/μL). Tests for hepatitis A, B and C and for cytomegalovirus, Epstein-Barr and herpes simplex viruses were negative as were routine serum autoantibodies. An ultrasound of the abdomen showed no evidence of biliary obstruction. A liver biopsy showed canalicular and cytoplasmic hepatocellular cholestasis, minimal lymphocytic infiltrates and spotty hepatocyte necrosis with no fibrosis or fat, suggestive of drug induced liver injury. Mesalamine was stopped and his symptoms resolved quickly. Six weeks after presentation all liver tests had returned to normal.

#### Key Points

Medication: | Mesalamine, 4 g daily
Pattern: | Hepatocellular (R=16)
Severity: | 3+ (jaundiced and hospitalized)
Latency: | 4 months
Recovery: | Complete within 6 weeks
Other medications: | None mentioned

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 23 | 101 | 0.9
4 months | 0 | 393 | 201 | 6.0 | Admission, liver biopsy
5.5 months | 6 weeks | 18 | 99 | 0.5 | Nausea, fatigue
Normal Values | | <42 | <190 | <1.2

#### Comment

A young man with Crohn disease developed jaundice and right upper quadrant pain 4 months after starting mesalamine. The prominence of pain, fatigue and nausea suggests that the injury was hepatocellular, which was also supported by the R ratio (~16) obtained at the time of hospital admission. On the other hand, the liver biopsy showed a prominence of cholestasis and only mild inflammation and necrosis, which led the authors to refer to the injury as cholestatic. Regardless, the course was self-limited and reasonably convincing as an example of mesalamine induced liver injury.

### Case 2. Acute hepatitis with jaundice attributed to mesalamine therapy.

[Modified from: Barroso N, Leo E, Guil A, Larrauri J, Tirado C, Zafra C, Gavilán F, Reina FR. [Non-immunoallergic hepatotoxicity due to mesalazine]. Gastroenterol Hepatol 1999; 22: 176-9. Spanish. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10349787)]

A 57 year old woman with inflammatory bowel disease was treated with oral mesalamine (5-aminosalcyclate) and developed nausea and epigastric pain followed by pruritus, dark urine and jaundice six months later. She had no history of liver disease or drug allergies. She denied alcohol use and was not taking other medications, over-the-counter drugs or herbal preparations. On examination, she was jaundiced but had no fever, rash or arthritis. Laboratory testing showed a total bilirubin of 15.1 mg/dL (direct 13.4), ALT 916 U/L, AST 1049 U/L, GGT 203 U/L, and alkaline phosphatase 462 U/L (Table). Complete blood cell counts and INR were normal. Tests for hepatitis A, B and C and for cytomegalovirus, Ebstein-Barr and herpes simplex viruses were negative as were serum ANA and SMA. An ultrasound of the abdomen was normal and showed no evidence of biliary obstruction. A liver biopsy showed an acute hepatitis without fibrosis or steatosis. Mesalamine was stopped, but she continued to worsen for several weeks with cholestatic features, serum bilirubin rising to 25.7 mg/dL and alkaline phosphate to 769 U/L. However, she did not develop signs of liver failure and INR values were only mildly elevated. Thereafter she began to improve, and all tests were normal three months later.

#### Key Points

Medication: | Mesalamine, 1.5 g daily
Pattern: | Hepatocellular (R=13.8 initially, falling to 1.7)
Severity: | 3+ (jaundiced and hospitalized)
Latency: | 6 months
Recovery: | Complete within 12 weeks
Other medications: | None

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
6 months | 0 | 916 | 462 | 15.1 | Admission, 2 weeks after onset of symptoms. R=13.8
7 months | 28 days | 467 | 670 | 23.8 | R=4.2
7.5 months | 38 days | 186 | 769 | 10.5 | R=1.7
8 months | 51 days | 104 | 458 | 3.1
10 months | 110 days | 28 | 234 | 0.5 | Asymptomatic
Normal Values | | <40 | <280 | <1.2

#### Comment

A woman with inflammatory bowel disease developed jaundice and itching 6 to 7 months after starting mesalamine. She was taking no other medications and other causes of acute liver injury were adequately excluded. While the initial laboratory tests showed a hepatocellular pattern of injury, the disease became distinctly cholestatic over the next several weeks. Recovery was delayed, but ultimately complete. Unlike cases associated with sulfasalazine, most cases of clinically apparent liver injury attributed to 5-ASA have had few features of hypersensitivity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mesalamine – Generic, Pentasa®

Balsalazide – Generic, Colazal®

Olsalazine – Dipentum®

Sulfasalazine – Generic, Azulfidine®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mesalamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mesalamine | 89-57-6 | C7-H7-N-O3 | Mesalamine Chemical Structure
Balsalazide | 80573-04-2 | C17-H15-N3-O6 | Balsalazide Chemical Structure
Olsalazine | 6054-98-4 | C14-H10-N2-O6.2Na | Olsalazine Chemical Structure
Sulfasalazine | 599-79-1 | C18-H14-N4-O5-S | Sulfasalazine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2017

Zimmerman HJ. Drugs used in inflammatory bowel disease. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 723-4. (Expert review of hepatotoxicity published in 1999 mentions that some patients with a hypersensitivity response and liver injury due to sulfasalazine redevelop similar injury when treated with 5-aminosalicylate or a derivative and that other instances of drug induced liver injury has been linked to mesalamine).
Wallace JL, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1350-62. (Textbook of pharmacology and therapeutics).
Fich A, Schwartz J, Braverman D, Zifroni A, Rachmilewitz D. Sulfasalazine hepatotoxicity. Am J Gastroenterol 1984; 79: 401-2. (32 year old man developed fever and rash 1 month after starting sulfasalazine for ulcerative colitis [bilirubin 0.4 mg/dL, AST 420 U/L, Alk P 70 U/L], recovering within 3 weeks of stopping, but redeveloped fever and conjunctivitis within hours of receiving a mesalamine enema [but liver tests were normal]). 6144268
Burke DA, Manning AP, Williamson JM, Axon AT. Adverse reactions to sulphasalazine and 5-amino salicylic acid in the same patient. Aliment Pharmacol Ther 1987 Jun; 1(3): 201-8. (A 26 year old man developed fever and rash 18 days after starting sulfasalazine for ulcerative proctitis [bilirubin 0.8 mg/dL, AST 2287 U/L, Alk P 2 times ULN], 21% eosinophils], resolving within 2 weeks, but with recurrence of fever within a day of starting 5-ASA enemas [liver tests remained normal]). 2908750
Riley SA, Mani V, Goodman MJ, Herd ME, Dutt S, Turnberg LA. Comparison of delayed-release 5-aminosalicylic acid (mesalazine) and sulfasalazine as maintenance treatment for patients with ulcerative colitis. Gastroenterology 1988; 94: 1383-9. (Among 100 patients with ulcerative colitis treated with sulfasalazine or mesalamine for 48 weeks found similar efficacy but fewer side effects with mesalamine, and .biochemical variables showed no consistent changes during treatment with either. drug). 2896139
Pineda JR, Leal JC, de la Morena E, Abreu L. [Hepatotoxicity: a new side effect of 5-aminosalicylic acid]. Med Clin (Barc) 1989; 93: 516. (37 year old woman with ulcerative colitis on sulfasalazine for 4 years developed ALT elevations within 2 weeks of switching to mesalamine [ALT 22 rising to 74 U/L], which resolved with switching back and recurred upon restarting mesalamine [ALT 139 U/L, symptoms, bilirubin and Alk P not mentioned]). 2622244
Gyssens IC, de Bock RF, Peetermans ME. [Sulfasalazine allergy: fever, skin rash, hepatitis and T-lymphocytes]. Ned Tijdschr Geneeskd 1989; 133: 1608-10. Dutch. (29 year old woman developed fever, rash and lymphadenopathy within 3 weeks of starting sulfasalazine for suspected Crohn disease [bilirubin not given, ALT 340 U/L, Alk P 419 U/L, 19% atypical lymphocytes], which resolved quickly on stopping, but with recurrence of fever and rash with subsequent treatment with TMP/SMZ [ALT normal]). 2571950
Rachmilewitz D. Coated mesalazine(5-aminosalicylic acid) versus sulphasalazine in the treatment of active ulcerative colitis: a randomised trial. BMJ 1989; 298 (6666): 82-6. (Among 220 patients with ulcerative colitis treated with a resin coated mesalamine vs sulfasalazine for 8 weeks, efficacy was similar, but side effects were more common with sulfasalazine, particularly hypersensitivity reactions, but events necessitating withdrawal of mesalamine included "increased liver function values and cholestasis"). 2563951
Brimblecombe R. Mesalazine: a global safety evaluation. Scand J Gastroenterol Suppl 1990; 172: 66. (Summary of safety data from 4 controlled trials of mesalamine in 932 patients with ulcerative colitis or Crohn disease, found common side effects of mesalamine no more frequent than with comparator arms or placebo; in postmarketing studies, the most frequently reported side effects were rash, nausea, dyspepsia, diarrhea, headache and "elevated liver function tests"; no mention of clinically apparent liver injury). 1972297
Hautekeete ML, Bourgeois N, Potvin P, Duville L, Reynaert H, Devis G, Adler M, et al. Hypersensitivity with hepatotoxicity to mesalazine after hypersensitivity to sulfasalazine. Gastroenterology 1992; 103: 1925-7. (21 year old woman with Crohn disease developed rash 3 weeks after starting sulfasalazine, which resolved rapidly on stopping, but recurred within 1 day of starting mesalamine which was followed by rash, conjunctivitis, worsening liver tests and coma [bilirubin 2.5 rising to 11.8 mg/dL, ALT 102 to 1379 U/L, Alk P 560 U/L, 10% atypical lymphocytes] and complicated course, but ultimate full recovery). 1360436
Gendre JP, Mary JY, Florent C, Modigliani R, Colombel JF, Soulé JC, Galmiche JP, Lerebours E, Descos L, Viteau JM, et al. Oral mesalamine (Pentasa) as maintenance treatment in Crohn's disease: a multicenter placebo-controlled study. The Groupe d'Etudes Thérapeutiques des Affections Inflammatoires Digestives (GETAID). Gastroenterology 1993; 104: 435-9. (Among 161 patients with Crohn disease in remission treated with mesalamine or placebo for up to 2 years, side effects were reported to be similar in the two groups and .no adverse biological effects were found.; no mention of hepatotoxicity or ALT levels). 8425685
Miner P, Hanauer S, Robinson M, Schwartz J, Arora S. Safety and efficacy of controlled-release mesalamine for maintenance of remission in ulcerative colitis. Pentasa UC Maintenance Study Group. Dig Dis Sci 1995; 40: 296-304. (Among 205 patients with ulcerative colitis in remission treated with mesalamine [Pentasa: 4 g daily] or placebo for 12 months, mentions that one of 103 patients on mesalamine developed "hepatitis" [AST 674 U/L, bilirubin and Alk P not given], which resolved within 1 month of stopping). 7851193
Marteau P, Nelet F, Le Lu M, Devaux C. Adverse events in patients treated with 5-aminosalicyclic acid: 1993-1994 pharmacovigilance report for Pentasa in France. Aliment Pharmacol Ther 1996; 10: 949-56. (Between 1993-1994, there were 130 adverse events due to mesalamine reported to a French Pharmacovigilance network, including 7 cases of liver test abnormalities; no specific information provided). 8971293
An oral preparation of mesalamine as long-term maintenance therapy for ulcerative colitis. A randomized, placebo-controlled trial. The Mesalamine Study Group. Ann Intern Med 1996; 124: 204-11. (Among 264 patients with ulcerative colitis treated with mesalamine [0.8 or 1.6 g daily] or placebo for 6 months, "no significant changes were seen in hepatic laboratory profiles" and there were no hepatic severe adverse events). 8533995
Stoschus B, Meybehm M, Spengler U, Scheurlen C, Sauerbruch T. Cholestasis associated with mesalazine therapy in a patient with Crohn's disease. J Hepatol 1997; 26: 425-8. (30 year old man developed jaundice without fever, rash or eosinophilia 4 months after starting mesalazine [4 g daily] for Crohn disease [bilirubin 6.0 mg/dL, ALT 393 U/L, Alk P 201 U/L], resolving within 6 weeks of stopping: Case 1). 9059966
Green JR, Gibson JA, Kerr GD, Swarbrick ET, Lobo AJ, Holdsworth CD, Crowe JP, et al. Maintenance of remission of ulcerative colitis: a comparison between balsalazide 3 g daily and mesalazine 1.2 g daily over 12 months. ABACUS Investigator group. Aliment Pharmacol Ther 1998; 12: 1207-16. (Among 95 patients with ulcerative colitis treated with balsalazide [3 g daily] or mesalamine [1.2 g daily] for up to 12 months, mean serum ALT levels decreased slightly on balsalazide [2 U/L] but increased on mesalamine [2 U/L], but no hepatic adverse events were mentioned). 9882028
Thomsen OO, Cortot A, Jewell D, Wright JP, Winter T, Veloso FT, Vatn M, Persson T, Pettersson E. A comparison of budesonide and mesalamine for active Crohn's disease. International Budesonide-Mesalamine Study Group. N Engl J Med 1998; 339: 370-4. (Among 182 patients with Crohn disease treated with budesonide [9 g once daily] or mesalamine [2 g twice daily] for 16 weeks, there were .no clinically significant changes in . biochemical variables in either group. and no hepatic serious adverse events reported). 9691103
Hanauer SB. Dose-ranging study of mesalamine (PENTASA) enemas in the treatment of acute ulcerative proctosigmoiditis: results of a multicentered placebo-controlled trial. The U.S. PENTASA Enema Study Group. Inflamm Bowel Dis 1998; 4: 79-83. (Among 287 patients with ulcerative proctitis treated with mesalamine [1, 2 or 4 g] or placebo enemas daily for 8 weeks, adverse events were similar with mesalamine as with placebo treatments). 9589293
Green JR, Lobo AJ, Holdsworth CD, Leicester RJ, Gibson JA, Kerr GD, Hodgson HJ, et al. Balsalazide is more effective and better tolerated than mesalamine in the treatment of acute ulcerative colitis. The Abacus Investigator Group. Gastroenterology 1998; 114: 15-22. (Among 101 patients with ulcerative colitis treated with balsalazide or mesalamine for 12 weeks, there were no serious hepatic adverse events and mean ALT levels decreased slightly during balsalazide [-5 U/L] but not mesalamine therapy [+1 U/L]). 9428213
Braun M, Fraser GM, Kunin M, Salamon F, Tur-Kaspa R. Mesalamine-induced granulomatous hepatitis. Am J Gastroenterol 1999; 94: 1973-4. (42 year old man with ulcerative colitis developed fever two weeks after starting mesalamine which continued for 6 weeks [bilirubin not provided, ALT 147 U/L, Alk P 800 U/L], which resolved only when mesalamine was stopped and recurred within 1 day of rechallenge). 10406274
Barroso N, Leo E, Guil A, Larrauri J, Tirado C, Zafra C, Gavilán F, Reina FR. [Non-immunoallergic hepatotoxicity due to mesalazine]. Gastroenterol Hepatol 1999; 22: 176-9. Spanish. (57 year old woman developed jaundice without fever or rash 6 months after starting mesalamine [bilirubin 15.1 mg/dL, ALT 916 U/L, Alk P 462 U/L], worsening for 2 weeks and then resolving over the following 3 months). 10349787
Deltenre P, Berson A, Marcellin P, Degott C, Biour M, Pessayre D. Mesalazine (5-aminosalicylic acid) induced chronic hepatitis. Gut 1999; 44: 886-8. (65 year old man developed serum enzyme elevations 8 months after starting mesalamine [ALT 13 times ULN], which remained elevated for 8 more months despite stopping simvastatin [ALT 12 times ULN, GGT 2 times ULN, bilirubin normal, ANA 1:500], but then resolved rapidly once mesalamine was stopped; a liver biopsy showed chronic hepatitis, interface hepatitis and portal fibrosis). 10323894
Oral balsalazide (Colazal) for ulcerative colitis. Med Lett Drugs Ther 2001; 43 (1109): 62-3. (Concise review of pharmacology, efficacy and safety of balsalazide shortly after its approval in the United States mentions that hepatitis and allergic reactions have been reported to occur with mesalamine, but not specifically with balsalazide). 11468602
Kruis W, Schreiber S, Theuer D, Brandes JW, Schütz E, Howaldt S, Krakamp B, et al. Low dose balsalazide (1.5 g twice daily) and mesalazine (0.5 g three times daily) maintained remission of ulcerative colitis but high dose balsalazide (3.0 g twice daily) was superior in preventing relapses. Gut 2001; 49: 783-9. (Among 133 patients with ulcerative colitis treated with balsalazide [3.0 vs 6.0 g daily] or mesalazine [1.5 g daily] for 26 weeks, no hepatic severe adverse events were observed; no mention of serum enzyme test results). 11709512
Ransford RA, Langman MJ. Sulphasalazine and mesalazine: serious adverse reactions re-evaluated on the basis of suspected adverse reaction reports to the Committee on Safety of Medicines. Gut 2002; 51: 536-9. (Serious adverse events reported to the Committee on Safety of Medications [UK] between 1991 and 1999 included 2400 due to sulfasalazine [SSZ] and 1100 mesalamine [MSA]; blood dyscrasias and skin reactions being more common with SSZ, interstitial nephritis and pancreatitis with MSA and hepatitis representing 6% of SSZ and 3.2% of MSA reports; no details given). 12235076
Hartleb M, Biernat L, Kochel A. Drug-induced liver damage--a three-year study of patients from one gastroenterological department. Med Sci Monit 2002; 8: CR292-6. (During a 3 year period, 14 patients with drug induced liver injury were seen at a referral hospital; causes included Augmentin [3], statins [3], tuberculosis drugs [2], and one case due to mesalamine: 57 year old woman found to have abnormal liver tests 6 weeks after starting mesalamine [bilirubin 0.7 mg/dL, ALT 1.9 times ULN, Alk P 2.9 times ULN], resolving after stopping). 11951073
Levine DS, Riff DS, Pruitt R, Wruble L, Koval G, Sales D, Bell JK, Johnson LK. A randomized, double blind, dose-response comparison of balsalazide (6.75 g), balsalazide (2.25 g), and mesalamine (2.4 g) in the treatment of active, mild-to-moderate ulcerative colitis. Am J Gastroenterol 2002; 97: 1398-407. (Among 154 patients with ulcerative colitis treated with balsalazide [6.75 or 2.25 g/daily] or [mesalamine 2.4 g daily], there were no severe hepatic adverse events and "no clinically significant changes in routine laboratory assessments"). 12094857
Mansfield JC, Giaffer MH, Cann PA, McKenna D, Thornton PC, Holdsworth CD. A double-blind comparison of balsalazide, 6.75 g, and sulfasalazine, 3 g, as sole therapy in the management of ulcerative colitis. Aliment Pharmacol Ther 2002; 16: 69-77. (Among 50 patients with ulcerative colitis receiving balsalazide or sulfasalazine has sole therapy for 8 weeks, there were no significant hepatic adverse events and "no significant changes in any of the...biochemical tests preformed"). 11856080
Green JR, Mansfield JC, Gibson JA, Kerr GD, Thornton PC. A double-blind comparison of balsalazide, 6.75 g daily, and sulfasalazine, 3 g daily, in patients with newly diagnosed or relapsed active ulcerative colitis. Aliment Pharmacol Ther 2002; 16: 61-8. (Among 57 patients with ulcerative colitis treated with either balsalazide or sulfasalazine for 12 weeks, there were no hepatic severe adverse events and "biochemistry assessment revealed no significant changes within or between the groups"). 11856079
Loftus EV Jr, Kane SV, Bjorkman D. Systematic review: short-term adverse effects of 5-aminosalicylic acid agents in the treatment of ulcerative colitis. Aliment Pharmacol Ther 2004; 19: 179-89. (Systematic review of 46 controlled trials of mesalazine, balsalazide and olsalazine for 2-12 weeks in ulcerative colitis found rates of adverse events similar to rates among placebo recipients, but lower than those with sulfasalazine; diarrhea in 2-10%, nausea in 3-8%, headache in 4-5%, abdominal pain in 4-6%, and rash in 2-4%; liver abnormalities reported in 2% of patients on mesalamine). 14723609
Hanauer SB, Strömberg U. Oral Pentasa in the treatment of active Crohn's disease: A meta-analysis of double-blind, placebo-controlled trials. Clin Gastroenterol Hepatol 2004; 2: 379-88. (An analysis of 3 controlled trials of oral mesalamine vs placebo for 16 weeks in a total of 615 patients with Crohn disease, does not discuss adverse events). 15118975
Hanauer SB, Sandborn WJ, Kornbluth A, Katz S, Safdi M, Woogen S, Regalli G, et al. Delayed-release oral mesalamine at 4.8 g/day (800 mg tablet) for the treatment of moderately active ulcerative colitis: the ASCEND II trial. Am J Gastroenterol 2005; 100: 2478-85. (Among 386 patients with ulcerative colitis treated with 2.4 vs 4.8 g of mesalamine daily for 6 weeks, no hepatic severe adverse events occurred and "there were no clinically significant changes in laboratory values in either treatment group"). 16279903
Once-daily mesalamine (Lialda) for ulcerative colitis. Med Lett Drugs Ther 2007; 49 (1257): 25-6. (Concise review of the efficacy and safety of an extended release mesalamine [Lialda] shortly after its approval in the US mentions adverse effects are similar to those of other mesalamine products including headache, flatulence, dyspepsia, abdomen pain and diarrhea; pancreatitis, but not hepatotoxicity, is also mentioned). 17375030
Hanauer SB, Sandborn WJ, Dallaire C, Archambault A, Yacyshyn B, Yeh C, Smith-Hall N. Delayed-release oral mesalamine 4.8 g/day (800 mg tablets) compared to 2.4 g/day (400 mg tablets) for the treatment of mildly to moderately active ulcerative colitis: The ASCEND I trial. Can J Gastroenterol 2007; 21: 827-34. (Among 301 patients with ulcerative colitis treated with mesalamine [2.4 or 4.8 g daily], there were no hepatic adverse events and "no clinically significant changes in laboratory values from baseline"). 18080055
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to mesalamine or other 5-ASA containing products). 18955056
Wiggins JB, Rajapakse R. Balsalazide: a novel 5-aminosalicylate prodrug for the treatment of active ulcerative colitis. Expert Opin Drug Metab Toxicol 2009; 5: 1279-84. (Review of safety and efficacy of balsalazide states that "although potential side effects are numerous, in clinical practice 5-ASAs are well tolerated"; no mention or discussion of hepatotoxicity). 19743890
Encapsulated mesalamine granules(Apriso) for ulcerative colitis. Med Lett Drugs Ther 2009; 51 (1312): 38-9. (Concise review of pharmacology, efficacy and safety of encapsulated mesalamine granules [Apriso] shortly after its approval in the United States mentions that hepatotoxicity has been reported with other mesalamine-containing products). 19448588
Scherl EJ, Pruitt R, Gordon GL, Lamet M, Shaw A, Huang S, Mareya S, Forbes WP. Safety and efficacy of a new 3.3 g b.i.d. tablet formulation in patients with mild-to-moderately-active ulcerative colitis: a multicenter, randomized, double-blind, placebo-controlled study. Am J Gastroenterol 2009; 104: 1452-9. (Among 249 patients with ulcerative colitis treated with balsalazide [3.3 g twice daily] or placebo, "there were no clinically significant or notable mean changes from baseline to week 8" in chemistry results). 19491859
Sandborn WJ, Regula J, Feagan BG, Belousova E, Jojic N, Lukas M, Yacyshyn B, et al. Delayed-release oral mesalamine 4.8 g/day (800-mg tablet) is effective for patients with moderately active ulcerative colitis. Gastroenterology 2009; 137: 1934-43. (Among 772 patients with ulcerative colitis treated with mesalamine [2.4 or 4.8 g daily] for 6 weeks, side effects were similar in the two groups with 10 severe adverse events, one of which was "drug hypersensitivity" but no details given). 19766640
Quiros JA, Heyman MB, Pohl JF, Attard TM, Pieniaszek HJ, Bortey E, Walker K, et al. Safety, efficacy, and pharmacokinetics of balsalazide in pediatric patients with mild-to-moderate active ulcerative colitis: results of a randomized, double-blind study. J Pediatr Gastroenterol Nutr 2009; 49: 571-9. (Among 68 children with ulcerative colitis treated with balsalazide [2.25 or 6.75 g daily] for 8 weeks, there were no hepatic adverse events and a "median decrease" in serum ALT levels). 19633577
Sandborn WJ, Korzenik J, Lashner B, Leighton JA, Mahadevan U, Marion JF, Safdi M, et al. Once-daily dosing of delayed-release oral mesalamine (400-mg tablet) is as effective as twice-daily dosing for maintenance of remission of ulcerative colitis. Gastroenterology 2010; 138: 1286-96, 1296. (Among 1023 patients with ulcerative colitis treated with mesalamine [1.6-2.4 g with once or twice daily dosing], one patient developed "cholestatic jaundice" and one cholangitis, but no details were provided). 20064514
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children; mesalamine and other 5-ASA based medications were not listed among the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to mesalamine, olsalazine or balsalazide). 20949552
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Extensive review of hepatotoxicity of agents used for IBD mentions that mesalamine only rarely causes acute liver injury, at an estimated rate of 3.2 cases per million prescriptions with predominantly cholestatic liver injury, with or without immunoallergic features). 20926880
Love BL, Miller AD. Extended-release mesalamine granules for ulcerative colitis. Ann Pharmacother 2012; 46: 1529-36. (Summary of 2 controlled trials of an extended release mesalamine [Apriso] in 562 adults with ulcerative colitis in remission mentions that adverse event rates were "often similar to that of placebo or active controls" and ALT elevations occurred in less than 3% of patients). 23115226
Masuda H, Takahashi Y, Nishida Y, Asai S. Comparison of the effect of mesalazine and sulfasalazine on laboratory parameters: a retrospective observational study. Eur J Clin Pharmacol 2012; 68: 1549-55. (Retrospective analysis of laboratory test results from 303 patients treated with mesalamine and 67 with sulfasalazine found no change in mean ALT levels with either drug). 22546896
Drugs for inflammatory bowel disease. Treat Guidel Med Lett 2012; 10 (115): 19-28. (Concise review mentions that aminosalicylates are first line treatment for ulcerative colitis, are available in multiple formulations, induce remissions in 35-50% and maintain remissions in 55-75% of patients, can cause mild-to-moderate degrees of nausea and vomiting, diarrhea, headache, abdominal pain, and have been reported to cause rare instances of allergic reactions and hepatotoxicity). 22361569
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to mesalamine or 5-ASA containing formulations). 23419359
Girelli F, Bernardi S, Gardelli L, Bassi B, Parente G, Dubini A, Serra L, et al. A New Case of DRESS syndrome induced by sulfasalazine and triggered by amoxicillin. Case Rep Rheumatol 2013; 2013: 409152. (53 year old woman with seronegative arthritis developed fever, sore throat, facial edema, lymphadenopathy and rash 6 weeks after starting sulfasalazine [bilirubin 2.7 mg/dL, ALT 350 U/L, Alk P 2959 U/L], with prompt clinical response to methylprednisolone therapy). 23936716
Raskin JB, Kamm MA, Jamal MM, Márquez J, Melzer E, Schoen RE, Szalóki T, et al. Mesalamine did not prevent recurrent diverticulitis in phase 3 controlled trials. Gastroenterology 2014; 147: 793-802. (Among 1182 adults with history of diverticulitis, recurrence rates were similar among those treated with mesalmamine [1.2, 2.4 or 4.8 g] or placebo daily; no mention of ALT elevations, but one patient died of hepatic failure and cirrhosis). 25038431
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to mesalamine, balsalazide or olsalazine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to mesalamine but none to balsalazide or olsalazine). 25754159
Bain JA. Mesalamine-induced fever: an important reminder to prescribers. J Gastrointestin Liver Dis 2015; 24: 259. (64 year old man developed recurrent fevers 2 months after starting mesalamine [no liver tests reported]). 26114191
Stelzer T, Kohler S, Marques Maggio E, Heuss LT. An unusual cause of febrile hepatitis. BMJ Case Rep 2015; 2015. pii: bcr2014205857. (51 year old man with ulcerative colitis developed fever 2 months after starting mesalamine [bilirubin normal, ALT 319 U/L, Alk P 385 U/L, ANA 1:320], biopsy showing granulomas and resolving rapidly with stopping mesalamine and a short course of prednisone). 26113581
Domínguez Jiménez JL, Pelado García EM, Copado Herrera R. [Mesalazine-induced acute hepatitis]. Gastroenterol Hepatol 2015; 38: 302-3. (53 year old man with ulcerative proctitis developed asymptomatic ALT elevations 2 months after starting mesalamine [bilirubin 0.9 mg/dL, ALT 1070 U/L, Alk P 85 U/L, no eosinophilia], with rapid improvement on stopping). 25458543
Oliveira AM, Carvalho R, Martins A, Reis J. Acute hepatitis in the DRESS syndrome. GE Port J Gastroenterol 2016; 23: 304-308. (22 year old woman with migratory arthritis developed rash and fever 3 weeks after starting sulfasalazine [peak bilirubin 2.1 mg/dL, ALT 2102 U/L, Alk P 573 U/L, eosinophilia], resolving with prednisolone therapy and stopping sulfasalazine). 28868484
Masood U, Sharma A, Nijjar S, Krenzer B. Unusual case of an alcoholic with liver injury from sulfasalazine use. J Basic Clin Pharm 2016; 8: 38-39. (57 year old man with alcoholism and rheumatoid arthritis developed jaundice 2 months after starting sulfasalazine [bilirubin 27.2 mg/dL, ALT 287 U/L, AST 363 U/L, Alk P 97 U/L, no eosinophilia], with ultrasound evidence of cirrhosis and ascites and ultimate recovery after stopping sulfasalazine). 28104973
Rocci E, Park K, Hutchens K, Winterfield L. First report of mesalamine (5-aminosalicylic acid) as the causative agent in a case of acute generalized exanthamous pustulosis. Dermatol Online J 2017; 23. pii: 13030. (73 year old man with ulcerative colitis developed pustular rash, leukocytosis, "renal failure" and ALT elevations 1 week after starting mesalamine, with rapid resolution on stopping [no specific results provided]). 28329471

## OTHER REFERENCE LINKS

1. Recent References on Mesalamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mesalamine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Mesalamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mesalamine)